# Apremilast

## OVERVIEW

### Introduction

Apremilast is an orally available, small molecule inhibitor of phosphodiesterase-4 (PDE-4) and an immunomodulating agent that is used for treatment of refractory psoriatic arthritis. Apremilast has been linked to a low rate of serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent acute liver injury.

### Background

Apremilast (a pre' mi last) is a small molecule inhibitor of the enzyme phosphodiesterase-4 (PDE-4) that is responsible for the degradation of cyclic adenosine monophosphate (cAMP), thereby blocking an important step in the inflammatory signaling of immune effector cells including T lymphocytes, monocytes and macrophages. Apremilast therapy has been shown to decrease the level of circulating proinflammatory cytokines and to improve symptoms in cases of psoriatic arthritis that have not responded to conventional therapies. Apremilast was approved as oral therapy of active psoriatic arthritis and for moderate-to-severe plaque psoriasis in the United States in 2014. It has been used experimentally and off-label to treat scalp and nail psoriasis and is under evaluation as therapy of other chronic inflammatory conditions. Apremilast is available in tablets of 10, 20 and 30 mg under the brand name Otezla. The recommended initial dose is 10 mg twice daily, which can be increased based upon tolerance to the recommended maintenance dose of 30 mg twice daily. Side effects include diarrhea, nausea, weight loss and headache which generally arise during the first few weeks of treatment and improve thereafter. Rare, but potentially severe adverse events include reactivation of tuberculosis, depression, severe infections and increased risk of malignancy.

### Hepatotoxicity

In multiple, large scale randomized controlled trials of apremilast in psoriasis and psoriatic arthritis, serum enzyme elevations were no more frequent among recipients of apremilast than placebo treatment. In these studies, serum ALT values rose above 150 U/L (3 to 4 times ULN) in 0.4% of apremilast- compared to 0.2% of placebo-recipients, and no patient developed clinically apparent liver injury with jaundice. Since approval there have been no published reports of hepatotoxicity attributed to apremilast, but it has had limited clinical use. Because apremilast is immunosuppressive, it may cause reactivation of viral infections including hepatitis B, but such cases have not been reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but experience with its use is limited).

### Mechanism of Injury

The mechanism by which apremilast might cause serum aminotransferase elevations or liver injury is not known. It is extensively metabolized by the liver predominantly by the cytochrome P450 system and is susceptible to drug-drug interactions with agents that induce or inhibit CYP 3A4 activity.

Drug Class: Dermatologic Agents, Psoriasis Agents

Other drugs used to treat psoriasis: acitretin, methotrexate, tumor necrosis factor (TNF)-inhibitors, secukinumab, ustekinumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Apremilast – Otezla®

DRUG CLASS

Dermatologic Agents, Psoriasis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Apremilast)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Apremilast | 608141-41-9 | C22-H24-N2-O7-S | Apremilast structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2017

Zimmerman HJ. Hepatotoxicity. The adverse effects of drugs and other chemicals upon the liver. 2nd edition. Philadelphia: Lippincott, 1999. (Textbook of drug induced liver injury published in 1999 before the availability of apremilast).
Samrao A, Berry TM, Goreshi R, Simpson EL. A pilot study of an oral phosphodiesterase inhibitor (apremilast) for atopic dermatitis in adults. Arch Dermatol 2012; 148: 890-7. (Among 16 patients with atopic dermatitis treated with apremilast [20 or 30 mg twice daily] for 6 months, symptom scores were improved and common side effects included nausea [33% and 90%] which was usually mild and decreased with continued therapy; no mention of ALT elevations or hepatotoxicity; one patient developed herpes zoster). 22508772
Papp K, Cather JC, Rosoph L, Sofen H, Langley RG, Matheson RT, Hu C, et al. Efficacy of apremilast in the treatment of moderate to severe psoriasis: a randomised controlled trial. Lancet 2012; 380 (9843): 738-46. (Among 352 patients with psoriasis treated with 3 doses of apremilast or placebo twice daily, response rates at 16 weeks were higher with apremilast in higher doses [10 mg 11%, 20 mg 29%, 30 mg 41%] than placebo [6%] and adverse events included nausea [11-18% vs 8%], diarrhea [7-14% vs 5%], and headache [6-10% vs 6%] and “no apparent safety concerns” were raised from routine and hepatic chemistry testing). 22748702
Schett G, Wollenhaupt J, Papp K, Joos R, Rodrigues JF, Vessey AR, Hu C, et al. Oral apremilast in the treatment of active psoriatic arthritis: results of a multicenter, randomized, double-blind, placebo-controlled study. Arthritis Rheum 2012; 64: 3156-67. (Among 204 patients with psoriatic arthritis treated with apremilast [20 mg twice daily or 40 mg once daily] or placebo for 12-24 weeks, clinical responses were more frequent with active drug [44% and 36%] than placebo [12%] and side effects included diarrhea, headache, nausea and fatigue which were greater with once daily dosing; one patient developed ALT elevations above 3 times ULN which resolved with lowering the dose, and there were no cases of liver related serious adverse events or clinically apparent liver injury with jaundice). 22806399
Pathan E, Abraham S, Van Rossen E, Withrington R, Keat A, Charles PJ, Paterson E, et al. Efficacy and safety of apremilast, an oral phosphodiesterase 4 inhibitor, in ankylosing spondylitis. Ann Rheum Dis 2013; 72: 1475-80. (Among 38 patients with ankylosing spondylitis treated with apremilast [30 mg twice daily] or placebo twice daily for 12 weeks, rates of clinical improvement did not differ between groups; side effects include loose stools and headaches, and there were no serious adverse events and no mention of ALT elevations). 22984171
Papp KA, Kaufmann R, Thaçi D, Hu C, Sutherland D, Rohane P. Efficacy and safety of apremilast in subjects with moderate to severe plaque psoriasis: results from a phase II, multicenter, randomized, double-blind, placebo-controlled, parallel-group, dose-comparison study. J Eur Acad Dermatol Venereol 2013; 27: e376-83. (Among 259 patients with plaque psoriasis treated with apremilast [20 mg] once or twice daily or placebo for 12 weeks, clinical responses were achieved in 24% of apremilast vs 10% of placebo recipients and side effects included nausea, diarrhea and headache; one patient on placebo and one on apremilast developed transient serum enzyme elevations but there were no hepatic related serious adverse events). 23030767
Kavanaugh A, Mease PJ, Gomez-Reino JJ, Adebajo AO, Wollenhaupt J, Gladman DD, Lespessailles E, et al. Treatment of psoriatic arthritis in a phase 3 randomised, placebo-controlled trial with apremilast, an oral phosphodiesterase 4 inhibitor. Ann Rheum Dis 2014; 73: 1020-6. (Among 504 patients with psoriatic arthritis treated with apremilast [20 or 30 mg] or placebo twice daily for 24 weeks, clinical responses at 16 weeks were more frequent with apremilast [31% and 40%] than placebo [19%], while ALT elevations occurred in 8% of apremilast- vs 13% of placebo-treated subjects). 24595547
Apremilast (Otezla) for psoriatic arthritis. Med Lett Drugs Ther 2014; 56 (1443): 41-2. (Concise review of the mechanism of action, clinical efficacy, safety and costs of apremilast shortly after its approval in the US as therapy of psoriatic arthritis, mentions adverse events of diarrhea, nausea and headache, but does not mention ALT elevations or hepatotoxicity). 24869713
Drugs for psoriasis. Med Lett Drugs Ther 2015; 57 (1470): 81-4. (Concise review of drugs for psoriasis including systemic therapies such as methotrexate, cyclosporine, acitretin, apremilast, tofacitinib and biologics such as TNF inhibitors, ustekinumab and secukinumab). 26035746
Drugs for psoriatic arthritis. Med Lett Drugs Ther 2015; 57 (1470): e88-92. (Concise review of drugs for psoriatic arthritis including NSAIDs, corticosteroids, methotrexate, leflunomide, sulfasalazine, cyclosporine, apremilast and several biologics such as TNF inhibitors, ustekinumab and secukinumab). 26035749
Kavanaugh A, Mease PJ, Gomez-Reino JJ, Adebajo AO, Wollenhaupt J, Gladman DD, Hochfeld M, et al. Long term (52-week) results of a phase III randomized, controlled trial of apremilast in patients with psoriatic arthritis. J Rheumatol 2015; 42: 479-88. (504 patients with psoriatic arthritis were treated with apremilast [20 or 30 mg] or placebo twice daily for 16 weeks and then re-randomized if not responding; among patients who finished 52 weeks on drug, side effects included diarrhea, nausea and headache; during the first 16 weeks of treatment, any elevation in ALT occurred in 8% of patients on apremilast vs 13% on placebo, while elevations above 150 U/L occurred in 0.3% on apremilast vs none [of 167] on placeb). 25593233
Paul C, Cather J, Gooderham M, Poulin Y, Mrowietz U, Ferrandiz C, Crowley J, et al. Efficacy and safety of apremilast, an oral phosphodiesterase 4 inhibitor, in patients with moderate-to-severe plaque psoriasis over 52 weeks: a phase III, randomized controlled trial (ESTEEM 2). Br J Dermatol 2015; 173: 1387-99. (Among 411 patients with plaque psoriasis treated with apremilast [30 mg] or placebo twice daily for 52 weeks, clinical responses at 16 weeks were more frequent with apremilast than placebo [29% vs 6%], and marked laboratory abnormalities were uncommon and similar in frequency in both groups, while clinical chemistry abnormalities “were transient and resolved with continued treatment”). 26357944
Papp K, Reich K, Leonardi CL, Kircik L, Chimenti S, Langley RG, Hu C, et al. Apremilast, an oral phosphodiesterase 4 (PDE4) inhibitor, in patients with moderate to severe plaque psoriasis: Results of a phase III, randomized, controlled trial (Efficacy and Safety Trial Evaluating the Effects of Apremilast in Psoriasis [ESTEEM] 1). J Am Acad Dermatol 2015; 73: 37-49. (Among 844 patients with plaque psoriasis treated with apremilast [30 mg] or placebo twice daily, clinical responses at 16 weeks were more frequent with apremilast than placebo [33% vs 15%], while serum ALT elevations above 3 times ULN occurred in 0.2% vs 0.4%, and there were no liver related serious adverse events). 26089047
Genovese MC, Jarosova K, Cieślak D, Alper J, Kivitz A, Hough DR, Maes P, et al. Apremilast in Patients with active rheumatoid arthritis: a phase II, multicenter, randomized, double-blind, placebo-controlled, parallel-group study. Arthritis Rheumatol 2015; 67: 1703-10. (Among 237 patients with rheumatoid arthritis with an inadequate response to methotrexate who were treated with apremilast [20 or 30 mg] or placebo twice daily for at least 16 weeks, clinical response rates were similar in all groups while gastrointestinal side effects were more common with apremilast; there were no liver related serious adverse events and no “clinical meaningful changes … in clinical chemistry variables”). 25779750
Busa S, Kavanaugh A. Drug safety evaluation of apremilast for treating psoriatic arthritis. Expert Opin Drug Saf 2015; 14: 979-85. (Review of the mechanism of action, clinical efficacy and safety of apremilast in psoriatic arthritis focuses upon gastrointestinal adverse events, depression and weight loss, but mentions that “abnormalities in laboratory parameters were infrequent, mostly transient and comparable across treatment groups”). 25827658
Haber SL, Hamilton S, Bank M, Leong SY, Pierce E. Apremilast: A Novel Drug for Treatment of Psoriasis and Psoriatic Arthritis. Ann Pharmacother 2016; 50: 282-90. (Systematic review of mechanism of action, clinical efficacy and safety of apremilast in severe psoriasis and psoriatic arthritis, mentions that the common side effects [diarrhea, nausea and headache] tend to occur in the first 2 weeks and resolve with time without dose modification and that severe adverse events, including ALT elevations, can occur but are usually transient and self-limited). 26783350
Rich P, Gooderham M, Bachelez H, Goncalves J, Day RM, Chen R, Crowley J. Apremilast, an oral phosphodiesterase 4 inhibitor, in patients with difficult-to-treat nail and scalp psoriasis: Results of 2 phase III randomized, controlled trials (ESTEEM 1 and ESTEEM 2). J Am Acad Dermatol 2016; 74: 134-42. (Among 1255 patients with nail or scalp psoriasis treated with apremilast [30 mg] or placebo twice daily for 16 weeks, psoriasis severity index scores improvement more on apremilast; no mention of adverse events). 26549249
Edwards CJ, Blanco FJ, Crowley J, Birbara CA, Jaworski J, Aelion J, Stevens RM, et al. Apremilast, an oral phosphodiesterase 4 inhibitor, in patients with psoriatic arthritis and current skin involvement: a phase III, randomised, controlled trial (PALACE 3). Ann Rheum Dis 2016; 75: 1065-73. (Among 505 patients with psoriatic arthritis treated with apremilast [20 or 30 mg] or placebo twice daily, clinical responses at 16 weeks were more frequent with drug [28-41%] than placebo [18%]; side effects were mild and included ALT elevations above 150 U/L in 0.5% vs 0%). 26792812
Bissonnette R, Pariser DM, Wasel NR, Goncalves J, Day RM, Chen R, Sebastian M. Apremilast, an oral phosphodiesterase-4 inhibitor, in the treatment of palmoplantar psoriasis: Results of a pooled analysis from phase II PSOR-005 and phase III Efficacy and Safety Trial Evaluating the Effects of Apremilast in Psoriasis (ESTEEM) clinical trials in patients with moderate to severe psoriasis. J Am Acad Dermatol 2016; 75: 99-105. (A pooled analysis of 2 trials of apremilast [30 mg] vs placebo twice daily in patients with palmoplantar psoriasis for 16 weeks, there was a higher rate of response with apremilast than placebo [48% vs 27%] and common side effects included diarrhea [19% vs 6%], nausea [16% vs 6%], and headache [15% vs 3%]; no mention of ALT elevations or hepatotoxicity). 27021239
Cutolo M, Myerson GE, Fleischmann RM, Lioté F, Díaz-González F, Van den Bosch F, Marzo-Ortega H, et al. A phase III, randomized, controlled trial of apremilast in patients with psoriatic arthritis: results of the PALACE 2 trial. J Rheumatol 2016; 43: 1724-34. (Among 484 patients with psoriatic arthritis treated with apremilast [20 or 30 mg] or placebo twice daily for up to 52 weeks, clinical responses by week 16 occurred in 32-37% of apremilast recipients vs 19% of placebo recipients, while ALT elevations above 150 U/L occurred in 0.7% vs 0.8% and there were no liver related serious adverse events). 27422893
Reich K, Gooderham M, Green L, Bewley A, Zhang Z, Khanskaya I, Day RM, et al. The efficacy and safety of apremilast, etanercept, and placebo, in patients with moderate to severe plaque psoriasis: 52-week results from a phase 3b, randomized, placebo-controlled trial (LIBERATE). J Eur Acad Dermatol Venereol 2016 Oct 21. (Among 250 patients with moderate to severe plaque psoriasis treated with apremilast [30 mg] or placebo twice daily or etanercept weekly, clinical responses at week 16 occurred in 40% on apremilast, 47% of etanercept and 12% on placebo; side effects of apremilast included nausea, diarrhea and headache while elevations of serum ALT above 3 times ULN occurred in 1.2% on apremilast and 1.2% on placebo, but none of etanercept). 27768242

## OTHER REFERENCE LINKS

1. Recent References on Apremilast: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Apremilast)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Apremilast) Trials on Apremilast: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Apremilast)